# Cranberry

## OVERVIEW

### Introduction

Cranberry is an evergreen shrub the fruits and leaves of which have been used in traditional medicine for bladder and digestive conditions, to promote wound healing, and more recently for prevention of recurrent urinary tract infections. Cranberry products have not been linked to serum aminotransferase elevations or to instances of clinically apparent liver injury with jaundice.

### Background

Cranberry products are derived from fruits and leaves of Vaccinium macrocarpon and other subspecies and have been used in traditional medicine to treat a variety of conditions, most commonly bladder symptoms and urinary tract infections. Cranberry fruit juice and extracts have a variety of constituents including anthocyanin dyes, catechins, triterpenoids, organic acids, glycosides, proteins and carbohydrates. Cranberries are commonly used as a food or condiment and in cooking. The anthocyanin pigments of cranberry are also used in commercial coloring. The active ingredients responsible for the purported medicinal properties of cranberry are not known. While cranberry has been purported to be beneficial for cognitive performance, wound healing, diabetes and stomach ailments, these effects have not been proven in human clinical trials. Cranberry products result in mild acidification of urine, and components have been shown to inhibit bacterial adherence to tissue surfaces. For these reasons, cranberry products have been extensively assessed as means of preventing recurrent urinary tract infections. While in vitro and in vivo studies suggest an effect on urinary tract infections, clinical trials have yielded conflicting results of their efficacy, some studies showing a partial effect and others none at all. Nevertheless, cranberry continues to be used for bladder symptoms and prevention of urinary tract infections. Cranberry is found in multiple commercial forms including as a fruit drink, as concentrates in tablets or capsules or as a component of multiingredient dietary supplements. The recommended daily dose ranges widely, typically 120 to 1600 mg as capsules daily or as 300 to 900 mL of cranberry juice. Cranberry is generally well tolerated without adverse events. With high doses, minor side effects may include diarrhea, abdominal discomfort and nausea. Ingestion of cranberry juice or extracts may have food-drug interactions, with reduced plasma levels and effects of proton pump inhibitors and histamine type 2 (H2) blockers.

### Hepatotoxicity

In multiple controlled trials of cranberry products vs. placebo as therapy of multiple conditions, side effects were reported to be uncommon, generally mild, and usually no more frequent with the herbal product than with placebo. There have been no convincing reports of serum enzyme elevations, jaundice or clinically apparent liver injury associated with cranberry use.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which cranberry might cause liver injury is unknown. When liver injury arises in association with a multiingredient dietary supplement containing cranberry, the effect of other components or contaminants should be suspected as the cause of the injury.

Drug Class: Herbal and Dietary Supplements

Other names: American Cranberry, Bearberry.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cranberry – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://www.nccih.nih.gov/health/cranberry)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cranberry | 91770-88-6 (https://pubchem.ncbi.nlm.nih.gov/substance/135278752) | Herbal | Not Applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 20 January 2023

Abbreviations: HDS, herbal and dietary supplements; UTIs, urinary tract infections.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not cranberry).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of cranberry).
Cranberry. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 238-41. (Compilation of short monographs on herbal medications and dietary supplements).
McMurdo ME, Bissett LY, Price RJ, Phillips G, Crombie IK. (2005). Does ingestion of cranberry juice reduce symptomatic urinary tract infections in older people in hospital? A double-blind, placebo-controlled trial. Age Ageing. (Among 376 elderly hospitalized patients treated with cranberry juice [300 mL] or placebo daily, rates of urinary tract infections [UTIs] and adverse events were similar in the two groups, although numerically lower rates of UTIs occurred in the cranberry group [3.7% vs 7.5%], the overall rate was quite low).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry does not list cranberry among the agents mentioned in reports of adverse reactions).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not cranberry).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, noni juice, Chinese herbs, vitamin A and anabolic steroids; cranberry is not discussed).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements but does not list or mention cranberry).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 15 of which [16%] were attributed to HDS products, but none were listed as containing cranberry).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention cranberry).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but no case was attributed specifically to cranberry).
Juthani-Mehta M, Van Ness PH, Bianco L, Rink A, Rubeck S, Ginter S, Argraves S, et al. (2016). Effect of cranberry capsules on bacteriuria plus pyuria among older women in nursing homes: a randomized clinical trial. JAMA. (Among 185 women, aged 65 years or older, in nursing homes who were treated with cranberry capsules [72 mg daily] or placebo for 1 year, UTIs occurred in 25% receiving cranberry and 29.5% placebo, with similar rates of symptomatic UTIs in the two groups; no description of adverse events).
Nicolle LE. (2016). Cranberry for prevention of urinary tract infection?: time to move on. JAMA. (Editorial in response to Juthani-Mehta [2016] concludes that cranberry should not be recommended as a means of preventing recurrent urinary tract infections, agents with known efficacy being available).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss cranberry).
Fu Z, Liska D, Talan D, Chung M. (2017). Cranberry reduces the risk of urinary tract infection recurrence in otherwise healthy women: a systematic review and meta-analysis. J Nutr. (Systematic review of the literature on cranberry for prevention of recurrent UTIs in women, identified 7 randomized controlled trials in 1498 patients that suggested a 26% decrease in UTIs rates with cranberry; adverse events were reported in only 5 studies, among which adverse events were similar or less common with cranberry vs placebo, and there were no serious adverse events: no mention of ALT elevations or hepatotoxicity).
Barclay J, Veeratterapillay R, Harding C. (2017). Non-antibiotic options for recurrent urinary tract infections in women. BMJ. (Review of non-antibiotic options for prevention of UTIs mentions that the efficacy of cranberry remains in doubt, but adverse events are typically no more frequent than with placebo; no mention of ALT elevations or hepatotoxicity).
Sihra N, Goodman A, Zakri R, Sahai A, Malde S. (2018). Nonantibiotic prevention and management of recurrent urinary tract infection. Nat Rev Urol. (Review of non-antibiotic means of management of recurrent urinary tract infections, mentions that studies of the efficacy of cranberry have had mixed results; no discussion of adverse events).
Masnadi Shirazi K, Shirinpour E, Masnadi Shirazi A, Nikniaz Z. (2021). Effect of cranberry supplementation on liver enzymes and cardiometabolic risk factors in patients with NAFLD: a randomized clinical trial. BMC Complement Med Ther. (Among 94 adults with nonalcoholic fatty liver disease treated with cranberry capsules [144 mg] or placebo daily for 6 months found that serum ALT levels fell in both groups, but that hepatic steatosis was less with cranberry; no mention of ALT elevations or hepatotoxicity).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], while one anicteric, self-limited hepatocellular case was scored as probably due to cranberry).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while cranberry was not implicated in any cases).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases of liver injury due to 79 different herbal products, the most common being He Shou Wu [n=91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; cranberry was not implicated in any cases).

## OTHER REFERENCE LINKS

1 Recent References on Cranberry: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Cranberry+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Cranberry: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cranberry)